# Tafasitamab

## OVERVIEW

### Introduction

Tafasitamab is a cytotoxic monoclonal antibody against CD19 that is used in combination with other antineoplastic agents to treat adults with relapsed or refractory diffuse large B cell lymphoma. Tafasitamab therapy is associated with a low rate of mild serum aminotransferase elevations during therapy but has not been linked to instances of clinically apparent liver injury.

### Background

Tafasitamab (ta” fa sit’ a mab) is Fc modified, humanized, cytolytic monoclonal antibody against CD19 that is used to treat adults with advanced, relapsed or refractory B cell malignancies, including diffuse large B cell lymphoma (DLBCL). Tafasitamab binds to CD19 which is expressed on pre- and mature B lymphocytes inducing antibody dependent cytolysis or apoptosis. Tafasitamab treatment lowers peripheral B cells, and chronic therapy is effective in inducing remissions in patients with relapsed or refractory B cell lymphomas. Tafasitamab in combination with lenalidomide was approved in the United States in 2020 for treatment of adults with relapsed or refractory DLBCL who are not candidates for autologous hematopoietic stem cell transplant. Tafasitamab is available as a powder for reconstitution in single use vials of 200 mg under the brand name Monjuvi. The recommended dose regimen is 12 mg/kg intravenously on 2 to 5 days of each 28 day course; for the initial 28 day cycle on days 1, 4, 8, 15, and 22, for cycles 2 and 3 on days 1, 8, 15 and 22, and for subsequent cycles on days 1 and 15. Tafasitamab should be administered with daily oral lenalidomide for no more than 12 cycles, but can be continued as monotherapy thereafter. Therapy should be continued until disease progression or unacceptable toxicity occur. Premedication with antihistamines, H2 blockers, or glucocorticoids is recommended. The combination of tafasitamab and lenalidomide has many adverse events that require monitoring and careful management. Common adverse events include neutropenia, anemia, thrombocytopenia, fatigue, cough, pyrexia, peripheral edema, respiratory tract infections, diarrhea, constipation, nausea, decreased appetite, and rash. Serious adverse events include severe myelosuppression, severe infections, infusion site reactions, and embryo-fetal toxicity. Tafasitamab should be administered only by health care providers with knowledge and experience with myelosuppressive immunotherapy of cancer.

### Hepatotoxicity

In small, preregistration open label trials, serum ALT elevations occurred in 11% of tafasitamab treated subjects but were generally transient and mild, and there were no instances of ALT elevations above 5 times the upper limit of normal (ULN) or clinically apparent liver injury with symptoms or jaundice. Since the approval of tafasitamab in 2020, there have been no case reports of clinically apparent liver injury attributed to its use. Monoclonal antibodies to CD19 have been used for other indications and similarly have been free of liver injury. These B cell directed monoclonal antibodies, however, are considered possible causes of reactivation of hepatitis B and prescreening for hepatitis B status is usually recommended. At least one case of reactivation of hepatitis B was reported in the follow up of the open label registration trial of tafasitamab and lenalidomide therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury except as a result of reactivation of hepatitis B).

### Mechanism of Injury

The causes of the mild liver test abnormalities during tafasitamab therapy are not clearly known but appear to be related to the underlying condition, other neoplastic agents (lenalidomide for instance) or comorbidities. Tafasitamab can cause hypersensitivity reactions including urticaria and rash, and liver injury might be a part of the immunoallergic reaction. Cases of reactivation of hepatitis B were not observed during prelicensure studies and should not occur with adequate prescreening and prophylaxis against reactivation.

### Outcome and Management

The product label for tafasitamab does not recommend monitoring of routine liver tests during therapy. Nevertheless, if detected, de novo elevations of serum aminotransferase levels above 5 times the ULN or baseline values should lead to temporary discontinuation and evaluation for other possible causes of liver injury, restarting therapy only when values return to normal or near normal and with careful subsequent monitoring. Screening of candidates for therapy for evidence of hepatitis B (for HBsAg and anti-HBc) is appropriate and, if positive, consultation for advice on the need for prophylaxis or prospective monitoring.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tafasitamab – Monjuvi®

DRUG CLASS

Antineoplastic Agents, Monoclonal Antibodies

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tafasitamab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tafasitamab | 1422527-84-1 (https://pubchem.ncbi.nlm.nih.gov/substance/381127365) | Monoclonal Antibody | Not Available

## SELECTED BIBLIOGRAPHY

References updated: 14 May 2024

Abbreviations: DLBCL, diffuse large B cell lymphoma; ULN, upper limit of the normal range.

FDA. Clinical Review. 2020.
https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761163Orig1s000MultidisciplineR.pdf (FDA Summary of the data the safety and efficacy of tafasitamab, submitted in support of the application for approval as therapy of diffuse large B cell lymphoma [DLBCL] mentions that tafasitamab had “acceptable safety” and ALT elevations arose in 11.1% of 222 treated patients in the safety cohort, but that all elevations were less than 5 times ULN, and no patient developed clinically apparent liver injury attributable to the monoclonal antibody).
Jurczak W, Zinzani PL, Gaidano G, Goy A, Provencio M, Nagy Z, Robak T, et al. Phase IIa study of the CD19 antibody MOR208 in patients with relapsed or refractory B-cell non-Hodgkin's lymphoma. Ann Oncol. 2018;29:1266-1272. (Among 92 adults with relapsed or refractory non-Hodgkin lymphoma treated with tafasitamab, the objective response rate and duration of response was highest in patients with DLBCL, and while adverse events were common, they were largely infusion reactions, myelosuppression, and infections; no mention of ALT elevations or hepatotoxicity). 29444231
Salles G, Duell J, González Barca E, Tournilhac O, Jurczak W, Liberati AM, Nagy Z, et al. Tafasitamab plus lenalidomide in relapsed or refractory diffuse large B-cell lymphoma (L-MIND): a multicentre, prospective, single-arm, phase 2 study. Lancet Oncol. 2020;21:978-988. (Among 81 adults with relapsed or refractory DLBCL treated with tafasitamab and lenalidomide in 28 day cycles for a median of 13 months, the objective response rate was 60% [complete 43%] and adverse events arose in all patients, which were serious in 51%, comprising largely myelosuppression and infections, but the authors state that therapy “was well tolerated”; aminotransferase elevations arose in 3% but no details provided). 32511983
Hoy SM. Tafasitamab: first approval. Drugs. 2020;80:1731-1737. (Review of the history of development, mechanism of action, pharmacology, clinical efficacy, and safety of tafasitamab shortly after its approval for use in the United States, mentions that virtually all recipients develop adverse events that are serious in half, but that tafasitamab has a “manageable safety profile”; no mention of ALT elevations or hepatotoxicity). 32946059
Delgado J, Papadouli I, Sarac SB, Moreau A, Hovgaard D, Gisselbrecht C, Enzmann H, et al. The European Medicines Agency review of tafasitamab in combination with lenalidomide for the treatment of adult patients with relapsed/refractory diffuse large B-cell lymphoma. Hemasphere. 2021;5:e666. (Summary of the European Medicines Agency review of tafasitamab for DLBCL mentions that adverse events arose in all 222 patients exposed to tafasitamab in the safety cohort, but that there were no cases of drug induced liver injury “and only 5 cases of elevated liver enzymes, all considered unrelated to therapy”). 34805769
In brief: tafasitamab (Monjuvi) for diffuse large B-cell. Med Lett Drugs Ther. 20237;65(1682):e133. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of tafasitamab shortly after its approval for use in relapsed or refractory DLBCL; no mention of ALT elevations or hepatotoxicity).
Belada D, Kopeckova K, Bergua Burgues JM, Stevens D, André M, Persona EP, Pichler P, et al. Safety and efficacy of tafasitamab with or without lenalidomide added to first-line R-CHOP for DLBCL: the phase 1b First-MIND study. Blood. 2023;142:1348-1358. (Among 83 adults with untreated DLBCL treated with open label tafasitamab and R-CHOP with or without lenalidomide, the overall response rate was slightly higher with lenalidomide [82% vs 76%] as was the serious adverse event rate [51% vs 42%]; no mention of ALT elevations of hepatotoxicity). 37369099
Qualls DA, Lambert N, Caimi PF, Merrill M, Pullarkat P, Godby RC, Bond DA, et al. Tafasitamab and lenalidomide in large B-cell lymphoma: real-world outcomes in a multicenter retrospective study. Blood. 2023;142:2327-2331. (Among 178 patients with DLBCL treated with tafasitamab and lenalidomide in routine practice at 11 institutions, the overall response rate was only 31% and progression-free survival only 1.9 months, while adverse event rates were similar including aminotransferase elevations in 1.3%). 37738563
Duell J, Abrisqueta P, Andre M, Gaidano G, Gonzales-Barca E, Jurczak W, Kalakonda N, et al. Tafasitamab for patients with relapsed or refractory diffuse large B-cell lymphoma: final 5-year efficacy and safety findings in the phase II L-MIND study. Haematologica. 2024;109:553-566. (A final 5 year follow up on the open label registration trial of tafasitamab and lenalidomide for relapsed or refractory DLBCL [Salles 2020] demonstrated an objective response rate of 58%, complete response rate of 41%, progression-free survival of 11.6 months and overall survival of 33.5 months with no new safety signals and no mention of ALT elevations or hepatotoxicity, but one case of reactivation of hepatitis B was reported for the initial year of tafasitamab and lenalidomide therapy; no details provided). 37646664

## OTHER REFERENCE LINKS

Recent References on Tafasitamab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tafasitamab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Tafasitamab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tafasitamab)